# Nitroprusside

## OVERVIEW

### Introduction

Sodium nitroprusside is a nitrovasodilator that is used intravenously for therapy of severe hypertension, hypertensive emergencies and heart failure. Despite its use for many years, nitroprusside has not been convincingly linked to cases of clinically apparent liver injury.

### Background

Sodium nitroprusside (nye" troe prus' ide) is a nonselective vasodilator that acts through release of nitric oxide to cause relaxation of smooth muscle cells of arterioles and venules. Nitroprusside is used predominantly to treat hypertensive emergencies, such as to lower blood pressure during acute aortic dissection or to improve cardiac output in severe congestive heart failure. Nitroprusside is unstable and must be administered intravenously with careful monitoring. It is rarely used for more than a few hours or days. Nitroprusside was approved for use in the United States in 1981 and continues to be used in critical or emergency situations. Sodium nitroprusside is available in solution for injection in 2 or 5 mL vials of 50 mg generically and under the brand name of Nitropress. The usual initial dose is 0.25 to 0.30 mcg/kg/minute by intravenous infusion with subsequent increase based upon clinical effect and blood pressure. The rate of infusion should be carefully managed; the average effective dose in children and adults is 3 mcg/kg/minute and the maximum recommended dose is 10 mcg/kg/minute. Nitroprusside has many side effects including hypotension, dizziness, headache, drowsiness, stupor, bradycardia, palpitations, flushing, nausea, metabolic acidosis and rash.

### Hepatotoxicity

Serum aminotransferase elevations during nitroprusside therapy are uncommon and are more likely attributable to hepatic ischemia due to hypotension, heart failure or anoxia. Nitroprusside has not been convincingly linked to cases of clinically apparent acute liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Sodium nitroprusside is metabolized in peripheral tissue to a cyanide radical which is converted to thiocyanate in the liver. Nitroprusside helps protect against ischemia reperfusion injury in animal models by improving hepatic microcirculation.

Drug Class: Antihypertensive Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nitroprusside – Generic, Nitropress®

DRUG CLASS

Antihypertensive Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=nitroprusside)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Sodium Nitroprusside | 13755-38-9 | C5-Fe-N6-Na2-O

## ANNOTATED BIBLIOGRAPHY

References updated: 29 April 2020

Zimmerman HJ. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 639-71. (Expert review of hepatotoxicity published in 1999; nitroprusside is not discussed).
De Marzio DH, Navarro VJ. Antihypertensives. Hepatotoxicity of cardiovascular and antidiabetic drugs: fibrates. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 522-6. (Review of hepatotoxicity of hypertensive agents does not discuss nitroprusside).
Eschenhagen T. Sodium nitroprusside. Treatment of hypertension. In, Brunton LL, Hillal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, p. 520. (Textbook of pharmacology and therapeutics).
(1989). Drugs for hypertensive emergencies. Med Lett Drugs Ther. (Brief overview of drugs for hypertensive emergencies, mentions that sodium nitroprusside is the most effective parenteral antihypertensive agent acting rapidly and its effects disappearing quickly with stopping infusions; adverse events are largely related to hypotension and venous pooling and can include fatigue, nausea, anorexia, disorientation, psychotic behavior, muscle spasms and more rarely hypothyroidism and cyanide poisoning; no mention of liver injury).
(2017). Drugs for hypertension. Med Lett Drugs Ther. (Brief overview of currently available drugs for hypertension, with guidelines on their use and information on prices and toxicities; nitroprusside not discussed).

## OTHER REFERENCE LINKS

1 Recent References on Nitroprusside: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(nitroprusside/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Nitroprusside: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=nitroprusside)